# Estazolam

## OVERVIEW

### Introduction

Estazolam is an orally available benzodiazepine used to treat insomnia. As with most benzodiazepines, estazolam has not been associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury from estazolam has not been reported and must be very rare, if it occurs at all.

### Background

Estazolam (es taz' oh lam) is a benzodiazepine used as a sleeping aid in the therapy of insomnia. The antianxiety (anxiolytic) and soporific activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Estazolam was approved in the United States in 1990 for the short term management of insomnia and is now rarely used, having been replaced by more effective and better tolerated agents. Estazolam is available in tablets of 1 and 2 mg in several generic forms and formerly under the brand name ProSom. The recommended initial oral dose for adults is 1 mg at bedtime, which can be increased to 2 mg nightly, but is not recommended as chronic therapy. The most common side effects of estazolam are dose related and include daytime drowsiness, lethargy, ataxia, dysarthria and dizziness. Tolerance develops to these side effects, but tolerance may also develop to the effects on insomnia. Estazolam like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) with continued use, the risks of physical and psychological dependence and severe potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for dependence, tolerance, and abuse.

### Hepatotoxicity

Estazolam, as with other benzodiazepines, is rarely associated with serum ALT elevations, and clinically apparent liver injury from estazolam is extremely rare, if it occurs at all. There have been no published case reports of symptomatic, acute liver injury from estazolam. Isolated cases of clinically apparent hepatitis have been reported with other benzodiazepines including alprazolam, chlordiazepoxide, clonazepam, diazepam, flurazepam, lorazepam, and triazolam. The clinical pattern of acute liver injury from benzodiazepines is typically cholestatic and mild-to-moderate in severity with a latency of 1 to 6 months and full recovery within 1 to 2 months. Fever and rash have not been described nor has autoantibody formation.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Estazolam is metabolized by the liver to inactive metabolites and excreted in the urine. Liver injury from benzodiazepines is probably due to the toxic effects of a rarely produced intermediate metabolite.

### Outcome and Management

The case reports of hepatic injury due to benzodiazepines were followed by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. No cases of acute liver failure or chronic liver injury due to estazolam have been described. There is no information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity may occur.

Drug Class: Sedatives and Hypnotics, Benzodiazepines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Estazolam – Generic, ProSom® (Trade name discontinued)

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=estazolam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Estazolam | 29975-16-4 | C16-H11-Cl-N4

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam, or temazepam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455. (Review of drug induced liver injury due to psychotropic drugs; rare instances of acute liver injury [usually cholestatic] have been reported with alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam; a hepatitis-like pattern has been reported with clonazepam and clorazepate; no mention of estazolam).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but compared to controls, relative risk of injury was increased only for clorazepate [8.3: estimated frequency 3.4 per 100,000 person-year exposures]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to estazolam or any other benzodiazepine, despite millions of prescriptions filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to estazolam or any other benzodiazepine).
(2023). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of drugs for chronic insomnia mentions that tolerance and dependence can occur with use of benzodiazepines and their use should be discouraged, and that benzodiazepines are CNS suppressants and can impair next day performance including driving and can cause complex behavior disorders, anterograde amnesia, dependence, tolerance, abuse and rebound insomnia; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Estazolam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Estazolam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Estazolam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Estazolam)